# Irinotecan

## OVERVIEW

### Introduction

Irinotecan and topotecan are semisynthetic derivatives of the plant alkaloid camptothecin and are used as antineoplastic agents in the therapy of colorectal, ovarian and non-small cell lung cancer. Both irinotecan and topotecan are associated with an appreciable rate of serum enzyme elevations during therapy, and irinotecan has been implicated in causing steatohepatitis when given as cyclic anticancer therapy.

### Background

Irinotecan (eye" ri noe tee' kan) and topotecan (toe" poe tee' kan) are semisynthetic derivatives of camptothecin, a plant alkaloid derived from the Chinese tree, Camptotheca acuminata. Both drugs appear to act by blocking DNA topoisomerase I, which is responsible for relaxation of supercoiled double stranded DNA so that replication can proceed. Topoisomerase I activity is particularly increased in cancer cells. Irinotecan and topotecan have antineoplastic activity against colorectal, non-small cell lung and breast cancer in vivo and in vitro. Irinotecan and topotecan were both approved for use in the United States in 1996 and continue to be used in oncology practice. Current formal indications for irinotecan are advanced colorectal cancer alone or in combination with other antineoplastic agents (usually fluorouracil). Irinotecan is available generically and under the brand name Camptosar in 2, 5 and 15 mL vials of 20 mg/mL. The typical dose varies is based upon body weight and is adjusted by whether it is used alone or in combination with other anticancer agents. The approved indications for topotecan include advanced or metastatic ovarian and cervical cancer and small cell lung cancer (after failure of first line chemotherapy). Topotecan is available in solution in 4 mg single dose vials generically and under the trade name Hycamtin. The typical dose varies by indication and body weight. Side effects of irinotecan and topotecan are similar and include bone marrow suppression, nausea, vomiting, abdominal pain, stomatitis, diarrhea, fatigue, hair loss and peripheral neuropathy. Infusions of irinotecan can be associated with severe diarrhea which is typically delayed and is treated with loperamide. Irinotecan also can cause an acute cholinergic syndrome marked by hypotension, diarrhea, sweating, lacrimation and fatigue, which is typically treated with atropine.

### Hepatotoxicity

Chemotherapy with irinotecan and topotecan in combination with other agents is associated with serum enzyme elevations in up 15% of patients depending upon the dose, other agents used, the frequency of monitoring and degree of elevation that is reported. The ALT elevations are usually asymptomatic and transient and may resolve without dose modification. Marked elevations occur in 1% to 4% of patients, but rarely require dose modification. Genetic variants in hepatic transporters and metabolic enzymes have been associated with predisposition to irinotecan toxicity, including OATP 1B1 (SLC01B1), UGT1A1 and CYP 3A4. However, the major toxicities of irinotecan are hematologic and diarrhea, and liver test elevations are rare causes of drug interruption or dose modification.

Irinotecan has been linked to chemotherapy induced steatosis and steatohepatitis. This can be shown by imaging or histologically, but is usually associated with minimal symptoms or laboratory test abnormalities. Cyclic therapy with irinotecan is often used to treat hepatic metastases from colorectal cancer in preparation for hepatic resection, and both steatosis and steatohepatitis have been found to be frequent in the nontumorous part of the liver at the time of resection. These abnormalities are often associated with mild to moderate elevations in serum aminotransferase and alkaline phosphatase levels, but are rarely symptomatic or accompanied by jaundice. Intriguingly, the steatosis and steatohepatitis associated with chemotherapy tends to persist long term, as opposed to sinusoidal obstruction syndrome and nodular regenerative hyperplasia which tend to improve or resolve over time. Steatohepatitis may be associated with an increased rate of complications after hepatic resection probably as a result of inhibition of hepatic regeneration. On the other hand, steatohepatitis following adjuvant irinotecan therapy has not been clearly associated with a decrease in survival or an increeased rate of hepatic failure after major hepatic resection. In addition, irinotecan has not been clearly associated with instances of sinusoidal obstruction syndrome or nodular regenerative hyperplasia, the common complications of oxaliplatin therapy, which is a frequently used alternative to irinotecan in managing advanced and metastatic colorectal cancer.

Likelihood score irinotecan: B (likely cause of clinically apparent liver injury).

Topotecan is a less frequently used topoisomerase inhibitor and has been associated with serum enzyme elevations in up to 50% of patients, but these have been transient, mild and not associated with jaundice or symptoms. Since licensure and more wide scale use, tocotecan has not been associated with instances of clinically apparent liver injury.

Likelihood score topotecan: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

Irinotecan is extensively metabolized in the liver and undergoes modification by CYP 3A and uridine diphosphate-glucuronosyltransferase (UGT1A1), the enzyme responsible for conjugation of bilirubin and is partially deficit in persons with Gilbert syndrome. As a consequence, adverse events to irinotecan therapy (such as neutropenia and diarrhea) are more common in patients with hyperbilirubinemia and Gilbert syndrome. The cause of steatosis and steatohepatitis from irinotecan therapy is not known, but may relate to generation of toxic intermediates of its metabolism.

### Outcome and Management

The hepatic injury caused by irinotecan and topotecan is usually mild and asymptomatic, and neither agent has been linked to cases of prolonged cholestasis or vanishing bile duct syndrome. The results of rechallenge after cases of clinically apparent insult have not been reported.

Drug Class: Antineoplastic Agents

Other Drugs in the Subclass, Topoisomerase Inhibitors: Etoposide, Teniposide

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Irinotecan – Generic, Camptosar®

Topotecan – Generic, Hycamtin®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Irinotecan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Irinotecan | 100286-90-6 | C33-H38-N4-O6.Cl-H | Irinotecan Chemical Structure
Topotecan | 119413-54-6 | C23-H23-N3-O5.Cl-H | Topotecan Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 27 April 2018

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of antineoplastic agents published in 1999; does not discuss the topoisomerase I inhibitors, irinotecan or topotecan).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan DP. Camptothecin analogues. Cytotoxic agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1710-2. (Textbook of pharmacology and therapeutics; mentions that irinotecan and topotecan are the only camptothecin analogues approved for clinical use and have activity in colorectal, ovarian and small cell lung cancer, and both can cause elevations in serum aminotransferase levels).
Bleiberg H, Cvitkovic E. Characterisation and clinical management of CPT-11 (irinotecan)-induced adverse events: the European perspective. Eur J Cancer 1996; 32A Suppl 3: S18-23. (In early studies, the major adverse events of irinotecan therapy in colorectal cancer were neutropenia [80%], nausea [78%], asthenia [81%], alopecia [81%], cholinergic syndrome [85%], and diarrhea [87%], which was usually delayed and sometimes required hospitalization; no discussion of ALT elevations or hepatotoxicity). 8943661
Merrouche Y, Extra JM, Abigerges D, Bugat R, Catimel G, Suc E, Marty M, et al. High dose-intensity of irinotecan administered every 3 weeks in advanced cancer patients: a feasibility study. J Clin Oncol 1997; 15: 1080-6. (Among 35 patients with advanced cancer, high doses of irinotecan were poorly tolerated, adverse events including severe neutropenia and diarrhea, "a moderate and reversible increase in hepatic transaminases was observed in three cases"). 9060548
Rougier P, Bugat R, Douillard JY, Culine S, Suc E, Brunet P, Becouarn Y, et al. Phase II study of irinotecan in the treatment of advanced colorectal cancer in chemotherapy-naive patients and patients pretreated with fluorouracil-based chemotherapy. J Clin Oncol 1997; 15: 251-60. (Among 213 French patients with advanced colorectal cancer treated with 1195 cycles of irinotecan [every 3 weeks], major side effects were neutropenia [47%], anemia [9%], thrombocytopenia [4%], diarrhea [37%] and cholinergic syndrome; ALT elevations occurred largely in patients with hepatic metastases). 8996150
Ardizzoni A, Hansen H, Dombernowsky P, Gamucci T, Kaplan S, Postmus P, Giaccone G, et al. Topotecan, a new active drug in the second-line treatment of small-cell lung cancer: a phase II study in patients with refractory and sensitive disease. The European Organization for Research and Treatment of Cancer Early Clinical Studies Group and New Drug Development Office, and the Lung Cancer Cooperative Group. J Clin Oncol 1997; 15: 2090-6. (Among 101 patients with small cell lung cancer treated with 403 courses of chemotherapy with topotecan, toxicity was mainly hematologic, liver test abnormalities occurred during 17% of courses, but were usually mild-to-moderate and transient with no instance of clinically apparent liver injury). 9164222
Bookman MA, Malmström H, Bolis G, Gordon A, Lissoni A, Krebs JB, Fields SZ. Topotecan for the treatment of advanced epithelial ovarian cancer: an open-label phase II study in patients treated after prior chemotherapy that contained cisplatin or carboplatin and paclitaxel. J Clin Oncol 1998; 16: 3345-52. (Among 139 women with refractory advanced ovarian cancer treated with topotecan, severe neutropenia occurred in 82%, but nonhematologic adverse events were mild; no mention of ALT elevations or hepatotoxicity). 9779711
Ohtsu T, Sasaki Y, Igarashi T, Murayama T, Kobayashi Y, Tobinai K. Unexpected hepatotoxicities in patients with non-Hodgkin's lymphoma treated with irinotecan(CPT-11) and etoposide. Jpn J Clin Oncol 1998; 28: 502-6. (All 3 patients with refractory lymphoma treated with irinotecan and etoposide [topoisomerase I and II inhibitors] developed ALT elevations >2.5 ULN and one developed jaundice, but all recovered). 9769785
Cersosimo RJ. Irinotecan: a new antineoplastic agent for the management of colorectal cancer. Ann Pharmacother 1998; 32: 1324-33. (Review of structure, pharmacology, efficacy and safety of irinotecan; the major dose limiting side effects are myelosuppression and diarrhea, and transient elevations in liver tests may occur [AST in 10.5% and Alk P in 13.2%]). 9876815
Levine EG, Cirrincione CT, Szatrowski TP, Canellos G, Norton L, Henderson IC. Phase II trial of topotecan in advanced breast cancer: a Cancer and Leukemia Group B study. Am J Clin Oncol. 1999; 22: 218-22. (Among 40 women with advanced, refractory breast cancer treated with topotecan in 21 day cycles, most toxicities were hematologic; no mention of ALT elevations or hepatotoxicity). 10362325
von Pawel J, Schiller JH, Shepherd FA, Fields SZ, Kleisbauer JP, Chrysson NG, Stewart DJ, et al. Topotecan versus cyclophosphamide, doxorubicin, and vincristine for the treatment of recurrent small-cell lung cancer. J Clin Oncol 1999; 17: 658-67. (Among 107 patients with refractory, recurrent small cell lung cancer treated with topotecan, severe neutropenia occurred in 38%, but nonhematologic toxicities were mild-to-moderate; no mention of ALT elevations or hepatotoxicity). 10080612
Tsutani H, Inai K, Kishi S, Morinaga K, Naiki H, Ueda T. Hepatic tumor rupture following effectual treatment with irinotecan in a patient with highly refractory malignant lymphoma. Int J Hematol 1999; 70: 178-80. (60 year old man with advanced, refractory non-Hodgkin lymphoma involving the liver had marked response to irinotecan therapy, with the hepatic mass shrinking from 8 x 6 cm to 4.5 x 3 cm, but subsequent hepatic rupture, autopsy showing necrotic nodular masses with fissures on the surface). 10561911
DeVore RF, Johnson DH, Crawford J, Garst J, Dimery IW, Eckardt J, Eckhardt SG, et al. Phase II study of irinotecan plus cisplatin in patients with advanced non-small-cell lung cancer. J Clin Oncol 1999; 17: 2710-20. (Among 52 patients with advanced non-small cell lung cancer treated with irinotecan and cisplatin side effects were common [100% had nausea and dyspnea], but hepatotoxicity and ALT elevations were not mentioned). 10561345
Mori K, Machida S, Yoshida T, Yoshida M, Kano Y, Tominaga K. A phase II study of irinotecan and infusional cisplatin with recombinant human granulocyte colony-stimulating factor support for advanced non-small-cell lung cancer. Cancer Chemother Pharmacol 1999; 43: 467-70. (Among 41 patients with advanced non-small cell lung cancer on cyclic irinotecan and cisplatin, transient, mild-to-moderate ALT or AST elevations occurred in 10 [24%]). 10321506
Van Cutsem E, Cunningham D, Ten Bokkel Huinink WW, Punt CJ, Alexopoulos CG, Dirix L, Symann M, et al. Clinical activity and benefit of irinotecan(CPT-11) in patients with colorectal cancer truly resistant to 5-fluorouracil(5-FU). Eur J Cancer 1999; 35: 54-9. (Among 107 patients with advanced colorectal cancer treated with irinotecan, side effects included alopecia [91%], nausea [88%], diarrhea [88%] and cholinergic syndrome [82%]; no mention of ALT elevations or hepatotoxicity). 10211088
Ong SY, Clarke SJ, Bishop J, Dodds HM, Rivory LP. Toxicity of irinotecan(CPT-11) and hepato-renal dysfunction. Anticancer Drugs 2001; 12: 619-25. (55 year old man with metastatic colorectal cancer developed severe neutropenia and diarrhea after irinotecan therapy and developed rise in bilirubin [0.7 to 4.6 mg/dL] and Alk P [~200 to 1150 U/L] and aminotransferase levels [above 5 times ULN], with slow ultimate recovery). 11487719
Mugishima H, Matsunaga T, Yagi K, Asami K, Mimaya J, Suita S, Kishimoto T, et al. Phase I study of irinotecan in pediatric patients with malignant solid tumors. J Pediatr Hematol Oncol 2002; 24: 94-100. (Among 28 children with refractory solid tumors treated with irinotecan, transient, mild-to-moderate liver tests abnormalities arose in 4 [14%]). 11990713
Rubbia-Brandt L, Audard V, Sartoretti P, Roth AD, Brezault C, Le Charpentier M, Dousset B, et al. Severe hepatic sinusoidal obstruction associated with oxaliplatin-based chemotherapy in patients with metastatic colorectal cancer. Ann Oncol 2004; 15: 460-6. (Among 153 patients undergoing hepatic resection for colon cancer, centrolobular congestion and necrosis were found in nontumor liver tissue in 51% of those who received neoadjuvant chemotherapy, but in none undergoing surgery alone; oxiplatin as the most frequently implicated agent; follow up biopsies often showed fibrosis). 14998849
Fernandez FG, Ritter J, Goodwin JW, Linehan DC, Hawkins WG, Strasberg SM. Effect of steatohepatitis associated with irinotecan or oxaliplatin pretreatment on resectability of hepatic colorectal metastases. J Am Coll Surg 2005; 200: 845-53. (Among patients undergoing hepatic resections for colorectal cancer metastases, steatohepatitis and liver injury were more common among the 14 who received oxaliplatin and/or irinotecan than 10 who received 5-FU alone or 13 given no chemotherapy). 15922194
Vauthey JN, Pawlik TM, Ribero D, Wu TT, Zorzi D, Hoff PM, Xiong HQ, et al. Chemotherapy regimen predicts steatohepatitis and an increase in 90-day mortality after surgery for hepatic colorectal metastases. J Clin Oncol 2006; 24: 2065-72. (Among 406 patients undergoing hepatic resection for colorectal metastases, preoperative chemotherapy with oxaliplatin was associated with sinusoidal dilatation [19% vs 2%], whereas irinotecan was associated with steatohepatitis [20% vs 4.4%], which was associated with higher 90 day mortality rates). 16648507
Karoui M, Penna C, Amin-Hashem M, Mitry E, Benoist S, Franc B, Rougier P, et al. Influence of preoperative chemotherapy on the risk of major hepatectomy for colorectal liver metastases. Ann Surg 2006; 243: 1-7. (Retrospective analysis of 67 patients undergoing hepatic resection of colorectal liver metastasis, found preoperative chemotherapy was associated with higher rates of complications [38% vs 14%] and hepatic failure [11% vs 0%] compared to no chemotherapy, despite no difference in degree of elevation of liver tests during first 10 postoperative days). 16371728
Takane H, Miyata M, Burioka N, Kurai J, Fukuoka Y, Suyama H, Shigeoka Y, Otsubo K, Ieiri I, Shimizu E. Severe toxicities after irinotecan-based chemotherapy in a patient with lung cancer: a homozygote for the SLCO1B1*15 allele. Ther Drug Monit 2007; 29: 666-8. (61 year old man with advanced non-small cell lung cancer with a genetic variant of organic anion transporter polypeptide 1B1(OAT) had increased serum levels of the first metabolite of irinotecan [SN-38] and experienced severe toxicity to irinotecan therapy). 17898662
Pawlik TM, Olino K, Gleisner AL, Torbenson M, Schulick R, Choti MA. Preoperative chemotherapy for colorectal liver metastases: impact on hepatic histology and postoperative outcome. J Gastrointest Surg 2007; 11: 860-8. (Among 212 patients with metastatic colorectal cancer undergoing resection, 55 had received irinotecan of whom 15 [27%] had marked steatosis and 2 [4%] steatohepatitis, compared to 59 patients who did not undergo chemotherapy of whom 2 [3%] had marked steatosis and none steatohepatitis). 17492335
Zorzi D, Laurent A, Pawlik TM, Lauwers GY, Vauthey J-N, Abdalla EK. Chemotherapy-associated hepatotoxicity and surgery for colorectal liver metastases. Brit J Surg 2007; 94: 274-86. (Systematic review of liver toxicity occurring after preoperative systemic chemotherapy for colorectal liver metastases, focuses upon steatosis caused by irinotecan and many other agents, sinusoidal obstruction syndrome from oxiplatin, and sclerosing cholangitis from floxuridine). 17315288
Eckardt JR, von Pawel J, Pujol JL, Papai Z, Quoix E, Ardizzoni A, Poulin R, et al. Phase III study of oral compared with intravenous topotecan as second-line therapy in small-cell lung cancer. J Clin Oncol 2007; 25: 2086-92. (Among 309 patients with advanced small cell lung cancer treated with either oral or intravenous topotecan, nonhematologic toxicities included diarrhea, fatigue, dyspnea, anorexia and nausea; no mention of ALT elevations or hepatotoxicity). 17513814
Seifart U, Fink T, Schade-Brittinger C, Hans K, Mueller C, Koschel G, Schroeder H, et al. Randomised phase II study comparing topotecan/carboplatin administration for 5 versus 3 days in the treatment of extensive-stage small-cell lung cancer. Ann Oncol 2007; 18: 104-9. (Among 100 patients with metastatic small cell lung cancer treated with topotecan and carboplatin in up to six cycles of either 3 or 5 days, hematologic toxicity [largely neutropenia] was the main side effect; no mention of ALT levels or hepatotoxicity). 17071939
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J. Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, several cases were attributed to antineoplastic agents [such as mercaptopurine, cyclophosphamide, docetaxel, temozolomide, bortezomib and imatinib], but none to irinotecan or topotecan). 18955056
Kudo D, Tsutsumi S, Akasaka H, Jin H, Ohashi T, Muroya T, Hasebe T, et al. [Predictive factors for histopathological liver injury in the patients who received preoperative systemic chemotherapy for colorectal liver metastases]. Gan To Kagaku Ryoho 2009; 36: 2025-7. Japanese. (Abstract only; among 47 patients undergoing hepatic resections for metastatic colorectal cancer, sinusoidal dilation but not steatohepatitis was more common among those who received preoperative oxaliplatin chemotherapy). 20037312
Cleary JM, Tanabe KT, Lauwers GY, Zhu AX. Hepatic toxicities associated with the use of preoperative systemic therapy in patients with metastatic colorectal adenocarcinoma to the liver. Oncologist 2009; 14: 1095-105. (Review of hepatic complications of chemotherapy for colorectal cancer; steatohepatitis has been associated with irinotecan therapy and BMI and linked to poor outcomes). 19880627
Choti MA. Chemotherapy-associated hepatotoxicity: do we need to be concerned? Ann Surg Oncol. 2009 Sep; 16: 2391-4. (Review on chemotherapy associated liver injury and its impact on surgical outcome after hepatic resection for colorectal cancer; irinotecan and 5-FU have been linked to steatosis and steatohepatitis). 19554374
Ramachandran R, Kakar S. Histological patterns in drug-induced liver disease. J Clin Pathol 2009; 62: 481-92. (Review of histology of drug induced liver injury discusses the "chemotherapy induced steatohepatitis" that is seen most frequently after irinotecan therapy). 19474352
Masi G, Loupakis F, Pollina L, Vasile E, Cupini S, Ricci S, Brunetti IM, et al. Long-term outcome of initially unresectable metastatic colorectal cancer patients treated with 5-fluorouracil/ leucovorin, oxaliplatin, and irinotecan (FOLFOXIRI) followed by radical surgery of metastases. Ann Surg 2009; 249: 420-5. (Among 196 patients with metastatic colorectal cancer who received chemotherapy, 37 were ultimately eligible for hepatic resection of the metastasis among whom all had sinusoidal dilation and 76% steatosis, which was severe in only 5% and associated with steatohepatitis in only 1). 19247029
Khan AZ, Morris-Stiff G, Makuuchi M. Patterns of chemotherapy-induced hepatic injury and their implications for patients undergoing liver resection for colorectal liver metastases. J Hepatobiliary Pancreat Surg 2009; 16: 137-44. (Review of liver injury from neoadjuvant therapy of colon cancer metastases and its clinical implications; irinotecan has been linked to steatosis and steatohepatitis, which may affect outcome of subsequent surgical resection of metastases). 19093069
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Review of the role and liver toxicity of chemotherapy for colorectal metastases; oxaliplatin is associated with sinusoidal injury and irinotecan with chemotherapy induced steatohepatitis [CASH]). 20949552
Chaudhury P, Hassanain M, Bouganim N, Salman A, Kavan P, Metrakos P. Perioperative chemotherapy with bevacizumab and liver resection for colorectal cancer liver metastasis. HPB (Oxford) 2010; 12: 37-42. (Among 35 patients with metastatic colorectal cancer who received bevacizumab before hepatic resection of liver metastases, 9 also received irinotecan but only 4 developed steatohepatitis and 2 jaundice postoperatively, but relationship of these events to irinotecan was not provided). 20495643
Takamoto T, Hashimoto T, Sano K, Maruyama Y, Inoue K, Ogata S, Takemura T, et al. Recovery of liver function after the cessation of preoperative chemotherapy for colorectal liver metastasis. Ann Surg Oncol 2010; 17: 2747-55. (Indocyanine green [ICG] testing of 55 patients receiving chemotherapy before hepatic resection for colorectal cancer metastases showed improvements in ISG clearance within 4 weeks of stopping therapy). 20425145
Ryan P, Nanji S, Pollett A, Moore M, Moulton CA, Gallinger S, Guindi M. Chemotherapy-induced liver injury in metastatic colorectal cancer: semiquantitative histologic analysis of 334 resected liver specimens shows that vascular injury but not steatohepatitis is associated with preoperative chemotherapy. Am J Surg Pathol 2010; 34: 784-91. (Among 334 patients undergoing hepatic resection for colorectal cancer metastases, marked hepatic steatosis was uncommon [9%] and correlated with BMI rather than chemotherapy, while sinusoidal lesions were present in 35% of cases and correlated with oxaliplatin use; neither correlated with immediate operative outcome). 20421779
Makowiec F, Möhrle S, Neeff H, Drognitz O, Illerhaus G, Opitz OG, Hopt UT, zur Hausen A. Chemotherapy, liver injury, and postoperative complications in colorectal liver metastases. J Gastrointest Surg 2011; 15: 153-64. (Among 102 patients undergoing hepatic resections for colorectal cancer metastases, steatosis was most common in those who had preoperative chemotherapy regardless of regimen [46% vs 18%], but BMI was a stronger risk factor and steatosis did not correlate with poor outcome). 21061183
Pilgrim CH, Thomson BN, Banting S, Phillips WA, Michael M. The developing clinical problem of chemotherapy-induced hepatic injury. ANZ J Surg 2012; 82: 23-9. (Review of types of liver injury from chemotherapy; oxaliplatin is associated with vascular and sinusoidal injury, whereas irinotecan is linked to steatohepatitis). 22507491
Narita M, Oussoultzoglou E, Chenard MP, Fuchshuber P, Rather M, Rosso E, Addeo P, et al. Liver injury due to chemotherapy-induced sinusoidal obstruction syndrome is associated with sinusoidal capillarization. Ann Surg Oncol 2012; 19: 2230-7. (Among 98 patients with colorectal cancer undergoing hepatic resection for metastases, 39 [36 of whom had received oxaliplatin] had changes of sinusoidal obstruction syndrome, and degree of changes correlated with isocyanine green [ICG] retention and overexpression of CD34, indicating capillarization of hepatic sinusoids). 22402811
Robinson SM, Wilson CH, Burt AD, Manas DM, White SA. Chemotherapy-associated liver injury in patients with colorectal liver metastases: a systematic review and meta-analysis. Ann Surg Oncol 2012; 19: 4287-99. (Histologic evaluation in 506 patients undergoing hepatic resection for colorectal cancer, showed that steatohepatitis was associated with irinotecan regimens, higher BMI and diabetes, whereas sinusoidal dilatation was not associated with chemotherapy; neither chemotherapy nor liver histology correlated with complications or deaths). 22766981
Lu QY, Zhao AL, Deng W, Li ZW, Shen L. Hepatic histopathology and postoperative outcome after preoperative chemotherapy for Chinese patients with colorectal liver metastases. World J Gastrointest Surg 2013; 5: 30-6. (Among 106 patients undergoing hepatic resections of colorectal cancer metastases after chemotherapy, 5 of 9 [56%] who received irinotecan had liver toxicity, including steatosis in 2 and steatohepatitis in 3). 23556058
Oshita F, Sugiura M, Murakami S, Kondo T, Saito H, Yamada K. Phase II study of nedaplatin and irinotecan in patients with extensive small-cell lung cancer. Cancer Chemother Pharmacol 2013; 71: 345-50. (Among 25 patients with small cell lung cancer treated with 4 cycles of nedaplatin and irinotecan, ALT elevations occurred in 10 [40%], but were transient and less than 5 times ULN in all). 23124649
Wolf PS, Park JO, Bao F, Allen PJ, DeMatteo RP, Fong Y, Jarnagin WR, et al. Preoperative chemotherapy and the risk of hepatotoxicity and morbidity after liver resection for metastatic colorectal cancer: a single institution experience. J Am Coll Surg 2013; 216: 41-9. (Among 384 patients undergoing liver resection for colorectal cancer metastases who had liver histology assessment, 35% had steatosis and 4% steatohepatitis, both of which were associated with higher BMI, diabetes and irinotecan chemotherapy, but these histologic featuers were not associated with major complications or death and no deaths were liver related). 23041049
von Pawel J, Jotte R, Spigel DR, O'Brien ME, Socinski MA, Mezger J, Steins M, et al. Randomized phase III trial of amrubicin versus topotecan as second-line treatment for patients with small-cell lung cancer. J Clin Oncol 2014; 32: 4012-9. (Among 637 patients with small-cell lung carcinoma treated wtih amrubicin or topotecan, overall survival was similar [7.5 vs 7.8 months] while hematologic adverse events were more common with topotecan, non-hematologic events rates were similar; no mention of ALT elevations or hepatotoxicity). 25385727
Enomoto Y, Inui N, Imokawa S, Karayama M, Hasegawa H, Ozawa Y, Matsui T, et al. Safety of topotecan monotherapy for relapsed small cell lung cancer patients with pre-existing interstitial lung disease. Cancer Chemother Pharmacol 2015; 76: 499-505. (Among 77 patients with relapsed small cell lung cancer treated with 1 to 7 courses of intravenous topotecan, adverse events were frequent including neutropenia [57%], febrile neutropenia [26%, one death] and exacerbation of preexisting interstitial lung disease [22%: 3 deaths]; no mention of hepatotoxicity). 26134440
Vincenzi B, Imperatori M, Picardi A, Vespasiani Gentilucci U, Gallo P, Fausti V, et al. Liver toxicity in colorectal cancer patients treated with first-line FOLFIRI-containing regimen: a single institution experience. Expert Rev Anticancer Ther 2015; 15: 971-6. (Among 156 patients with coloreactal cancer treated with a "backbone" regimen of folinic acid, fluorouracil and irinotecan ["FOLFIRI"], most had serum enzyme elevations before starting [64%], and serum enzymes rose overall during the first 3 months of treatment [median peak level of ALT 168 U/L, Alk P 289 U/L, and bilirubin 1.2 mg/dL], while abnormal liver tests led to course delay in 16%, dose reduction in 8%, but discontinuation in only 2% and death in 0% of patients). 26112080
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 were attributed to antineoplastic agents [5.5%], but none were attributed to irinotecan to topotecan). 25754159
Goto K, Ohe Y, Shibata T, Seto T, Takahashi T, Nakagawa K, Tanaka H, Tet al; JCOG0605 investigators. Combined chemotherapy with cisplatin, etoposide, and irinotecan versus topotecan alone as second-line treatment for patients with sensitive relapsed small-cell lung cancer (JCOG0605): a multicentre, open-label, randomised phase 3 trial. Lancet Oncol 2016; 17: 1147-57. (Among 180 patients with relapsed small cell lung cancer treated with topotecan vs combination chemotherapy, overall survival was less with topotecan [12 vs 18 months], while adverse events were somewhat less including febrile neutropenia [7% vs 31%] and serious adverse events [4% vs 10%], while rates of ALT elevations were similar [37% vs 35% overall, above 5 times ULN 1% vs 2%], and there were 2 topotecan related deaths [both pulmonary]). 27312053
Vigano L, De Rosa G, Toso C, Andres A, Ferrero A, Roth A, Sperti E, Majno P, Rubbia-Brandt L. Reversibility of chemotherapy-related liver injury. J Hepatol. 2017; 67 (1): 84-91. (Among 524 liver resections done on 429 patients, rates of sinusoidal obstruction were less in patients whose resection was done more than 270 days after chemotherapy [19% vs 40%] as was nodular regenerative hyperplasia [8% vs 24%], but not steatosis [24% vs 36%] or steatohepatitis [10% vs 16%], but only NRH correlated with an increased liver failure rate [8% vs 3%]). 28284915
Duwe G, Knitter S, Pesthy S, Beierle AS, Bahra M, Schmelzle M, Schmuck RB, et al. Hepatotoxicity following systemic therapy for colorectal liver metastases and the impact of chemotherapy-associated liver injury on outcomes after curative liver resection. Eur J Surg Oncol 2017; 43: 1668-81. (Review of the hepatotoxicity of adjuvant therapy for metastatic colorectal cancer mentions that irinotecan is associated with steatosis and steatohepatitis which may impair hepatic regeneration, but have not been clearly linked to poor long term outcomes). 28599872
Poveda A, Del Campo JM, Ray-Coquard I, Alexandre J, Provansal M, Guerra Alía EM, Casado A, et al. Phase II randomized study of PM01183 versus topotecan in patients with platinum-resistant/refractory advanced ovarian cancer. Ann Oncol 2017; 28: 1280-7. (Among 59 patients with refractory advanced ovarian cancer treated with topotecan or an experimental anticancer agent, ALT elevations occurred in 51% of topotecan treated subjects, but most were mild and all were transient and less than 5 times ULN). 28368437

## OTHER REFERENCE LINKS

1. Recent References on Irinotecan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Irinotecan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Irinotecan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Irinotecan)